# Bremelanotide

## OVERVIEW

### Introduction

Bremelanotide is a parenterally administered melanocortin receptor agonist that is used to treat female hypoactive sexual desire disorder. Bremelanotide has been reported to cause mild serum enzyme elevations during therapy and has been implicated in rare instances of clinically apparent acute liver injury.

### Background

Bremelanotide (bre” me lan’ oh tide) is a melanocortin receptor agonist that has been developed as a therapy of female hypoactive sexual desire disorder, which is defined as low sexual desire that causes marked distress or interpersonal difficulties. Melanocortin receptors are found largely in the central nervous system and skin and are associated with effects on appetite and sexual desire. In the skin, melanocortin receptors activate melanocytes and cause increase in pigmentation. Bremelanotide engages several melanocortin receptors (MCR), predominantly MC_1_R and MC_4_R, the latter of which is believed to modulate sexual desire. In several randomized, placebo controlled trials bremelanotide, given as a self-administered, on-demand subcutaneous injection at least 45 minutes before anticipated sexual activity, was found to improve indices of sexual desire and reduce sexual distress in a proportion of patients. Therapy did not consistently increase numbers of sexually satisfying events. Bremelanotide was approved for use in the United States in 2019 as therapy for premenopausal women with hypoactive sexual desire disorder. Bremelanotide is available in autoinjection pens as an solution of 1.75 mg in 0.3 mL under the brand name Vyleesi. The recommended dose is 1.75 mg subcutaneously by self-injection given at least 45 minutes before anticipated sexual activity. Common side effects include nausea (40%, particularly with the first injection), flushing (20% ), injection site reactions (13%) and headache (11%). Uncommon adverse reactions have included increase in blood pressure, severe nausea and vomiting, arthralgia, restless leg syndrome, and local hyperpigmentation.

### Hepatotoxicity

In preregistration clinical trials, serum enzyme elevations were reported in small numbers of bremelanotide treated patients but in a similar proportion of subjects receiving placebo. A single case of acute hepatitis arose in a patient who had received 10 injections of bremelanotide over a one year period with marked elevations in serum aminotransferase levels, minimal increases in alkaline phosphatase, and mild jaundice which resolved after discontinuation. There have been no instances of acute liver failure or chronic liver injury attributed to bremelanotide, but the total clinical experience with this drug has been limited. Thus, acute liver injury from bremelanotide may occur but is rare.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which bremelanotide causes liver injury is not known. Bremelanotide is a synthetic peptide analogue of melanocyte stimulating hormone alpha (MSHα), and its metabolism is by hydrolysis of amide bonds and digestion by cellular peptidases. Bremelanotide has minimal drug-drug interactions and is unlikely to be inherently hepatotoxic or immunogenic.

Drug Class: CNS Stimulants; Female Hypoactive Sexual Desire Disorder Agents

See also Flibanserin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bremelanotide – Vyleesi®

DRUG CLASS

Female Hypoactive Sexual Desire Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Bremelanotide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bremelanotide | 189691-06-3 | C50-H68-N14-O10

## ANNOTATED BIBLIOGRAPHY

References updated: 20 August 2021

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999, before the availability of bremelanotide).
Schimmer BP, Funder JW. Adrenocorticotropic hormone, adrenal steroids, and the adrenal cortex. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 845-61. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2019/210557Orig1s000MultidisciplineR.pdf (FDA website with product label and comprehensive multidiscipline review of the efficacy and safety of bremelanotide that supported its approval for use in female hypoactive sexual desire disorder, mentions that a single case of acute hepatitis occurred in a 52 year old woman who developed fatigue and weight loss approximately 10 days after receiving her last of 20 doses of bremelanotide with peak ALT 1163 U/L, Alk P 164 U/L and bilirubin 7.6 mg/dL, resolving over the next several months with normal values in follow up 1 to 2 years later [Simon 2019]).
Clayton AH, Althof SE, Kingsberg S, DeRogatis LR, Kroll R, Goldstein I, Kaminetsky J, et al. (2016). Bremelanotide for female sexual dysfunctions in premenopausal women: a randomized, placebo-controlled dose-finding trial. Womens Health (Lond). (Among 293 premenopausal women with hypoactive sexual desire disorder treated with self-administered, as desired injections of bremelanotide [0.75, 1.25 and 1.75 mg] or placebo for 12 weeks, the numbers of sexually satisfying events increased by 0.7 per month with bremelanotide vs 0.2 with placebo, and adverse events included nausea [18-24% vs 3%], flushing [14-17% vs 0], and headache [9-14% vs 3%], while “clinical laboratory findings showed no clinically significant trends”).
Clayton AH, Lucas J, DeRogatis LR, Jordan R. (2017). Phase I randomized placebo-controlled, double-blind study of the safety and tolerability of bremelanotide coadministered with ethanol in healthy male and female participants. Clin Ther. (Among 24 healthy adults given intranasal bremelanotide with or without alcohol or placebo on days 1, 4 and 7 in a three-way cross over study, side effects were similar in the 3 groups, although “a small number of participants had mild increases in ALT” of 1.5 to 3.0 times the upper limit of normal, one transiently rising to an ALT of 124 U/L, largely attributed to the alcohol).
(2019). Bremelanotide (Vyleesi) for hypoactive sexual desire disorder. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, and safety of bremelanotide shortly after its approval in the US mentions side effects of nausea [40%], flushing, injection site reactions, headaches, and vomiting as well as transient increases in blood pressure and focal hyperpigmentation; no mention of ALT elevations or hepatotoxicity).
Dhillon S, Keam SJ. (2019). Bremelanotide: First Approval. Drugs. (Review of the structure, mechanism of action, history of development, pharmacokinetics, clinical efficacy and safety of bremelanotide shortly after its approval for use in the US mentions a case of acute icteric hepatitis that occurred in a patient who had received 8 doses of bremelanotide over a one year period in an open label extension study).
Kingsberg SA, Clayton AH, Portman D, Williams LA, Krop J, Jordan R, Lucas J, et al. (2019). Bremelanotide for the treatment of hypoactive sexual desire disorder: two randomized phase 3 trials. Obstet Gynecol. (Among 1267 premenopausal women with hypoactive sexual desire disorder treated for 24 weeks with bremelanotide or placebo self-administered injections as needed before anticipated sexual activity, scores of sexual desire improved and those of sexual distressed decreased with bremelanotide and adverse reactions were common but generally mild-to-moderate in severity, and “no clinically significant effects on clinical laboratory tests…were observed”).
Simon JA, Kingsberg SA, Portman D, Williams LA, Krop J, Jordan R, Lucas J, et al. (2019). Long-term safety and efficacy of bremelanotide for hypoactive sexual desire disorder. Obstet Gynecol. (Among 684 patients enrolled in an open-label extension study after participation in a 24 week controlled trial of bremelanotide of whom only 272 completed the extension period; while the authors state that “no new safety signals were observed”, one patient developed an acute hepatitis after receiving a year of therapy with serum aminotransferases rising to above 20 times ULN and bilirubin to twice ULN with minor elevations present six but not 12 months later).
Kingsberg SA, Simon JA. (2020). Female hypoactive sexual desire disorder: a practical guide to causes, clinical diagnosis, and treatment. J Womens Health (Larchmt). (Review of the pathogenesis, clinical features and therapy of female hypoactive sexual desire disorder).
Spielmans GI. (2021). Re-analyzing Phase III bremelanotide trials for "hypoactive sexual desire disorder" in Women. J Sex Res. (Critical analysis of the two controlled trials of bremelanotide [Kingberg 2019] in regard to changes in primary outcome during the course of analysis and the rather modest improvement in symptom scores).
Kingsberg SA, Clayton AH, Portman D, Krop J, Jordan R, Lucas J, Simon JA. (2021). Failure of a meta-analysis: a commentary on Glen Spielmans's "Re-Analyzing Phase III Bremelanotide Trials for 'Hypoactive Sexual Desire Disorder in Women'". J Sex Res. (Reply to the critical analysis of Spielmans [2021] stressing the statistical rigor of the analysis and acceptance of the clinical endpoints used by the FDA).

## OTHER REFERENCE LINKS

1 Recent References on Bremelanotide: from PubMed.gov (http://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bremelanotide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Bremelanotide: from ClinicalTrials.gov (http://clinicaltrials.gov/ct2/results?term=Bremelanotide)